# Exemestane

## OVERVIEW

### Introduction

Exemestane is a steroidal inhibitor of aromatase which effectively blocks estrogen synthesis in postmenopausal women and is used as therapy of estrogen receptor positive breast cancer, usually after resection and after failure of tamoxifen. Exemestane has been associated with a low rate of serum enzyme elevations during therapy and rare instances of clinically apparent liver injury.

### Background

Exemestane (ex" e mes' tane) is an aromatase inhibitor that acts as an antiestrogen and is used to treat postmenopausal women with estrogen receptor positive breast cancer. Aromatase is the enzyme responsible for the conversion of testosterone to estrone (E1) and of androstenedione to estradiol (E2). Highest levels of aromatase are found in the ovary and placenta, which are the major sources of estrogen in premenopausal women. However, aromatase is also found in other tissues, such as liver, kidney, adrenals, brain, muscle and subcutaneous fat where it is also active in producing estrogens, although at low levels. These tissues are the major source of estrogen in postmenopausal women. Inhibitors of aromatase were developed to block the synthesis of estrogen in the peripheral tissues and, thus, as antiestrogen therapy of estrogen receptor positive breast cancer in postmenopausal women. Exemestane is a steroidal, specific aromatase inhibitor which has little or no effect on adrenal glucocorticoid or mineralocorticoid synthesis. Exemestane was approved for use in postmenopausal women with estrogen receptor positive breast cancer in the United States in 1999. Exemestane is available in 25 mg tablets in generic forms and under the brand name Aromasin. Current indications are as adjuvant therapy in postmenopausal women with estrogen sensitive breast cancer after failure, intolerance or as replacement of tamoxifen. Exemestane is given in doses of 25 mg once daily by mouth for up to five years. Common side effects include hot flashes, night sweats, arthralgias, fatigue, dizziness, nervousness, insomnia, nausea, weight gain and headache. Uncommon, but potentially severe adverse reactions include reduction in body mineral density and embryo-fetal toxicity.

### Hepatotoxicity

Serum enzymes are reported to be elevated in 4% to 11% of women treated with exemestane, but these elevations are usually mild, asymptomatic and self-limited, rarely requiring dose modification. There have been very rare instances of clinically apparent liver injury associated with exemestane therapy, typically arising withinone to four months of starting treatment and typically presenting with a cholestatic pattern of enzyme elevations. Immunoallergic features (fever, rash, eosinophilia) are uncommon as are autoantibody formation. Some instances have been severe with signs of hepatic failure, but most cases were self-limited. Unlike tamoxifen, exemestane has not been associated with development of fatty liver disease, steatohepatitis or cirrhosis.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The acute form liver injury attributed to exemestane use is probably due to an idiosyncratic reaction to a metabolite of the medication rather than its antiestrogenic effects. Exemestane is metabolized in the liver by the cytochrome P450 system, largely via CYP 3A4. Drug-drug interactions can occur with CYP 3A4 inducers.

### Outcome and Management

Liver injury attributed to exemestane is usually mild and self-limited, ranging in severity from transient, asymptomatic serum enzyme elevations to mild clinically apparent acute liver injury. Cases of acute liver failure have been reported in women on exemestane therapy, but the relationship of the injury to the aromatase inhibitor has not been well defined. There is little evidence for cross sensitivity to liver injury between exemestane and tamoxifen or even among the various aromatase inhibitors (which have distinctly different chemical structures).

References on the safety and hepatotoxicity of exemestane are given below as well as together with those on anastrozole and letrozole after the Overview section on Aromatase Inhibitors.

Drug Class: Antineoplastic Agents, Antiestrogens, Aromatase Inhibitors

Other Drugs in the Subclass, Aromatase Inhibitors: Anastrozole, Letrozole

## CASE REPORT

### Case 1. Clinically apparent, acute liver injury due to exemestane.

[Modified from: Bao T, Fetting J, Mumford L, Zorzi J, Shahverdi K, Jeter S, Herlong F, et al. Severe prolonged cholestatic hepatitis caused by exemestane. Breast Cancer Res Treat 2010; 121: 789-91. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/19834799)]

A 47 year old postmenopausal woman with estrogen receptor positive breast cancer developed fatigue, followed by pruritus and jaundice 3 weeks after starting adjuvant therapy with exemestane (25 mg daily). She had no history of liver disease, risk factors for viral hepatitis or alcohol abuse. She had no history of drug allergies and her only other medication was naproxen (550 mg), taken intermittently for a sports related wrist injury. On presentation, serum bilirubin was 3.8 mg/dL, ALT 438 U/L, AST 170 U/L and alkaline phosphatase 181 U/L. These were known to have been normal in the past (Table). Tests for hepatitis A, B and C were negative as were autoantibodies. Despite stopping exemestane, jaundice worsened, and she developed intractable pruritus for which she was hospitalized and treated with ursodiol, cholestyramine, phenobarbital, lorazepam and venlafaxine. She slowly improved, but still had minor elevations in serum enzyme 6 months after stopping exemestane.

#### Key Points

Medication: | Exemestane (25 mg daily)
Pattern: | Hepatocellular initially (R=7.0), later cholestatic (R=0.8)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 3 weeks
Recovery: | 24 weeks, incomplete
Other medications: | Naproxen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 38 | 56 | 0.8 | Breast cancer diagnosis
3 weeks | 0 | 438 | 181 | 3.8 | Exemestane stopped
6 weeks | 3 weeks | 73 | 188 | 16.2 | Ursodiol started
7 weeks | 4 weeks | 54 | 184 | 21.2 | R=0.8
3 months | 2 months | 74 | 197 | 19.7
5 months | 4 months | 186 | 546 | 1.5
7 months | 6 months | 83 | 266 | 0.5
Normal Values | | <40 | <115 | <1.2

* Values from Table 1.

#### Comment

The clinical presentation of cholestatic liver injury 3 weeks after starting exemestane, in the absence of other likely causes, is convincing evidence that the liver injury was due to the aromatase inhibitor. Long term follow up was limited, the last liver tests results provided were still abnormal and no information was provided of whether other antiestrogens were tolerated.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Exemestane – Generic, Aromasin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Exemestane)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Exemestane | 107868-30-4 | C20-H24-O2 | Exemestane Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2017

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999, before the availability of exemestane and other aromatase inhibitors).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of tamoxifen mentions that nonalcoholic fatty liver disease is the most common form of liver injury due to tamoxifen which has also been reported to cause peliosis hepatis, acute hepatitis, submassive hepatic necrosis and liver cancer; the aromatase inhibitors are not discussed).
Moy B, Lee RJ, Smith M. Anti-estrogen therapy. Natural products in cancer chemotherapy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1756-9. (Textbook of pharmacology and therapeutics).
Lønning PE. Pharmacology and clinical experience with exemestane. Exp Opin Invest Drugs 2000; 9: 1897-905. (Review of pharmacology, clinical efficacy and safety of exemestane, mentions a low rate of toxicity, side effects being largely due to the antiestrogen activity). 11060785
Paridaens R, Dirix L, Lohrisch C, Beex L, Nooij M, Cameron D, Biganzoli L, et al.; European Organization for the Research and Treatment of Cancer (EORTC) - Investigational Drug Branch for Breast Cancer (IDBBC). Mature results of a randomized phase II multicenter study of exemestane versus tamoxifen as first-line hormone therapy for postmenopausal women with metastatic breast cancer. Ann Oncol 2003; 14: 1391-8. (Among 122 postmenopausal women with breast cancer [estrogen receptor positive] randomized to tamoxifen versus exemestane, ALT or AST elevations occurred in equal numbers of both groups [37%], but were >5 times ULN in 3% of tamoxifen versus 11% of exemestane recipients; no clinically apparent liver injury reported). 12954578
Bohn Sarmiento U, Aguiar Bujanda D, Aguiar Morales J, Rodriguez San Román JL. Toxic hepatitis secondary to oral administration of exemestane. Rev Oncol 2003; 5: 550-1. Not in PubMed (65 year old woman with breast cancer developed jaundice 2 months after switching from tamoxifen to exemestane [bilirubin 13.8 mg/dL, ALT 69 U/L, Alk P 690 U/L], resolving within 4 months of stopping).
Coombes RC, Kilburn LS, Snowdon CF, Paridaens R, Coleman RE, Jones SE, Jassem J, et al.; Intergroup Exemestane Study. Survival and safety of exemestane versus tamoxifen after 2-3 years' tamoxifen treatment (Intergroup Exemestane Study): a randomised controlled trial. Lancet 2007; 369 (9561): 559-70. (Among 4724 postmenopausal women with estrogen receptor positive breast cancer treated with tamoxifen for 2-3 years and then randomized to continue tamoxifen or switch to exemestane, no hepatotoxicity was reported and ALT results not mentioned). 17307102
Paridaens RJ, Dirix LY, Beex LV, Nooij M, Cameron DA, Cufer T, Piccart MJ, et al. Phase III study comparing exemestane with tamoxifen as first-line hormonal treatment of metastatic breast cancer in postmenopausal women: the European Organisation for Research and Treatment of Cancer Breast Cancer Cooperative Group. J Clin Oncol 2008; 26: 4883-90. (Among 371 women with breast cancer in a prospective controlled trial, ALT elevations above 5 times ULN occurred in 8% on exemestane versus 4% on tamoxifen, but no serious adverse events were attributed to either drug). 18794551
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to antiestrogens such as exemestane, letrozole, anastrozole or tamoxifen). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to exemestane or the other antiestrogens). 20949552
Bao T, Fetting J, Mumford L, Zorzi J, Shahverdi K, Jeter S, Herlong F, et al. Severe prolonged cholestatic hepatitis caused by exemestane. Breast Cancer Res Treat 2010; 121: 789-91. (47 year old postmenopausal woman with breast cancer developed jaundice 3 weeks after starting exemestane [bilirubin 3.8 rising to 21.2 mg/dL, ALT 438 U/L, Alk P 181 U/L], with prolonged jaundice and pruritus and incomplete resolution 24 weeks later: Case 1). 19834799
Rabaglio M, Ruepp B; Soft/Text/Perche Steering Committee. Death due to liver failure during endocrine therapy for premenopausal breast cancer. Acta Oncol 2010; 49: 874-6. (Among 4500 women enrolled in endocrine therapy of premenopausal breast cancer, 2 developed acute liver failure, one on tamoxifen and one exemestane; 50 year old woman developed jaundice 2 years after starting exemestane [bilirubin 23.2 mg/dL, ALT 182 U/L, Alk P 382 U/L], with progressive liver failure and death, injury being attributed to concurrent alcoholism). 20482225
Dowsett M, Cuzick J, Ingle J, Coates A, Forbes J, Bliss J, Buyse M, et al. Meta-analysis of breast cancer outcomes in adjuvant trials of aromatase inhibitors versus tamoxifen. J Clin Oncol 2010; 28: 509-18. (Meta analysis of trials comparing aromatase inhibitors to tamoxifen as adjuvant therapy of breast cancer in postmenopausal women; no discussion of hepatotoxicity or rates of ALT elevations). 19949017
Aromatase inhibitors for adjuvant treatment of postmenopausal breast cancer. Med Lett Drugs Ther 2011 13; 53 (1366):47-8. (Concise review of the aromatase inhibitors and their role in therapy of breast cancer in postmenopausal women; no discussion of adverse events). 21659970
Lintermans A, Neven P, Paridaens R. Drug safety evaluation of exemestane. Expert Opin Drug Saf 2011; 10: 473-87. (Review of structure, mechanism of action, pharmacology, clinical efficacy and safety of exemestane; no mention of hepatotoxicity or changes in ALT levels). 21428848
van de Velde CJ, Rea D, Seynaeve C, Putter H, Hasenburg A, Vannetzel JM, Paridaens R, et al. Adjuvant tamoxifen and exemestane in early breast cancer(TEAM): a randomised phase 3 trial. Lancet 2011; 377 (9762): 321-31. (Prospective trial of exemestane in women with early breast cancer found abnormal liver "function" tests in 4% of those treated with exemestane). 21247627
Tomao F, Spinelli G, Vici P, Pisanelli GC, Cascialli G, Frati L, Panici PB, Tomao S. Current role and safety profile of aromatase inhibitors in early breast cancer. Expert Rev Anticancer Ther 2011; 11: 1253-63. (Review of efficacy and safety of aromatase inhibitors in early breast cancer; no discussion of hepatotoxicity or ALT elevations). 21916579
Teplinsky E, Cheung D, Weisberg I, Jacobs RE, Wolff M, Park J, Friedman K, et al. Fatal hepatitis B reactivation due to everolimus in metastatic breast cancer: case report and review of literature. Breast Cancer Res Treat 2013; 141: 167-72. (56 year old woman with breast cancer developed jaundice approximately 2 months after starting everolimus and exemestane [bilirubin 8 mg/dL, ALT 1758 U/L, Alk P 154 U/L, HBsAg and HBV DNA present without IgM anti-HBc], with progressive liver failure and death in 2 weeks despite starting tenofovir therapy). 24002736
Goss PE, Ingle JN, Pritchard KI, Ellis MJ, Sledge GW, Budd GT, Rabaglio M, et al. Exemestane versus anastrozole in postmenopausal women with early breast cancer: NCIC CTG MA.27--a randomized controlled phase III trial. J Clin Oncol 2013; 31: 1398-404. (Among 7576 women with early breast cancer randomized to anastrozole or exemestane for 5 years, event-free survival was the same while mild bilirubin and ALT elevations were more common with exemestane [1.6% and 1.4%] than anastrozole [0.6% and 0.6%]; no mention of instances of clinically apparent liver injury). 23358971
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury seen over a ten year period at 8 US medical centers, 7 were attributed to antiestrogens used in cancer chemotherapy including 4 to tamoxifen, 2 exemestane and 1 letrozole). 25754159
Jerusalem G, Mariani G, Ciruelos EM, Martin M, Tjan-Heijnen VC, Neven P, Gavila JG, et al. Safety of everolimus plus exemestane in patients with hormone-receptor-positive, HER2-negative locally advanced or metastatic breast cancer progressing on prior non-steroidal aromatase inhibitors: primary results of a phase IIIb, open-label, single-arm, expanded-access multicenter trial (BALLET). Ann Oncol 2016; 27: 1719-25. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27358383) (Among 2131 patients with hormone receptor positive breast cancer progressing despite antiestrogen therapy who were treated with the combination of everolimus and exemestane for an average of 5 months, adverse events were common but mostly attributable to everolimus; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1. Recent References on Exemestane: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Exemestane/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Exemestane: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Exemestane)